# Introduction

Drug induced liver injury is an uncommon but important and challenging form of liver disease. When evaluating a patient with new-onset liver disease, drugs, including prescription drugs, over-the-counter preparations, dietary supplements, vitamins and herbal medications, must always be considered as a possible cause. Indeed, the possibility must be entertained even if another cause may seem obvious, such as hepatitis B or C. The reason for this is that drug induced liver injury can be severe and even fatal, but is usually reversed by discontinuation of the offending agent. To continue a medication in the face of drug induced liver injury can have serious consequences.

Drug induced liver injury is a growing challenge because of the ever increasing number of drugs used in medical care and the increasing number of individuals who take them. Among the thousands of drugs available today, several hundred have been linked to liver injury, but the clinical pattern of liver injury is diverse and can mimic almost any form of liver disease. Drug induced liver injury can present in a pattern that is similar to acute hepatitis, chronic hepatitis, acute liver failure, biliary obstruction, or fatty liver disease. To keep track of which drugs cause liver injury and what pattern is typical of each agent is challenging to even the most dedicated subspecialist in the area. Furthermore, the literature on drug induced liver injury is large and dispersed to publications in many disciplines – pharmacology, internal medicine, hepatology, gastroenterology, pediatrics, and surgery. Publications on drug induced liver disease often appear as short reports or letters to the editor that are difficult to access, including many that appear in foreign language journals that may not be available in local medical libraries. As a result, it is difficult to keep abreast of the literature, and literature searches on specific medications are often incomplete. While there are several excellent textbooks on drug induced liver disease, they may be difficult to obtain and are rapidly out of date as new medications are introduced and more literature appears.

For these reasons, the National Institute of Diabetes and Digestive and Kidney Diseases (https://www2.niddk.nih.gov/) in collaboration with the National Library of Medicine (https://www.nlm.nih.gov/) and the Drug-Induced Liver Injury Network study group has established the LiverTox website, dedicated to providing up-to-date, comprehensive clinical information on drug induced liver injury for both the general physician and the specialist. The LiverTox website is a dynamic resource that began with information on a limited number of agents, building slowly to include all commercially available drugs and dietary supplements that have potential to cause liver injury. Each section includes an overview of the medication (its chemical nature, mechanism of action, indications, recommended doses and regimens, and common side effects) followed by a concise description of the pattern and course of the associated liver injury. Sections are supported by case histories with actual laboratory test results. Each section also includes a comprehensive bibliography, each reference of which is briefly annotated and has links to PubMed where the abstract or, in some cases, the whole article may be obtained. Sections also have descriptions of the chemical structure and links to package insert information. The LiverTox website is designed to be a practical and useful adjunct for the clinician confronting a patient with liver injury who is taking a medication that may be causative, and is a resource for medical and research specialists in the field. The text of LiverTox is deliberately concise and clear, avoiding highly technical or specialized terminology and using abbreviations sparingly. The background sections have a glossary for medical terms. These features make LiverTox a resource for lay persons and patients seeking information on the possible harmful effects of medications on the liver. The website invites input from its users as well as advice on how to improve accuracy and usefulness of the information.

For more information about LiverTox, see About LiverTox.